# Ibuprofen

## OVERVIEW

### Introduction

Ibuprofen is a commonly used nonsteroidal antiinflammatory (NSAID) drug which is available both by prescription and over-the-counter. Ibuprofen is considered to be among the safest NSAIDs and is generally well tolerated but can, nevertheless, rarely cause clinically apparent and serious acute liver injury particularly when given in high therapeutic doses.

### Background

Ibuprofen (eye" bue proe' fen) is a propionic acid NSAID similar to ketoprofen and naproxen. Like other NSAIDs, ibuprofen is a potent inhibitor of cellular cyclooxygenases (Cox-1 and Cox-2) which blocks the formation of prostaglandin, prostacyclin and thromboxane products, important mediators of inflammation and pain. Ibuprofen has analgesic as well as antipyretic and antiinflammatory activities. Ibuprofen was approved for use by prescription in the United States in 1974 and was made available over-the-counter in 1984. Currently, more than 17 million prescriptions for ibuprofen are filled yearly, a number that does not include its vast over-the-counter use. Ibuprofen is used for treatment of mild-to-moderate forms of joint pain and arthritis from trauma, osteoarthritis or rheumatoid arthritis. Ibuprofen is also active against other forms of pain including headache and dysmenorrhea. The recommended dose for chronic arthritis in adults is 400 to 800 mg orally three to four times daily, whereas intermittent dosing with lesser amounts of 200 to 600 mg daily is used for headache and pain. Ibuprofen is available both by prescription and over-the-counter in multiple generic formulations, either alone or in combination with other analgesics, antihistamines or anticholinergic agents usually in doses of 200, 400, 600, or 800 mg. Pediatric formulations are also available. Common brand names for ibuprofen include Advil, Motrin, Nuprin, Rufen and Trendar. Ibuprofen is also found in many combination formulations for dysmenorrhea, headache, allergies, upper respiratory tract symptoms and other pain syndromes under names such as Dristan, Haltran, and Aches-N-Pain. Side effects are not common, but may include headache, dizziness, somnolence, dyspepsia, nausea, abdominal discomfort, heartburn, diarrhea, peripheral edema, infertility, fetal toxicity, and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs such as naproxen include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, infertility, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, and Stevens Johnson syndrome.

Overdose with ibuprofen (2 to 20 g) can cause drowsiness, nausea and vomiting, and sweating and sometimes with higher doses (above 10 g), coma, metabolic acidosis, renal failure, liver injury, cardiovascular collapse, and death.

### Hepatotoxicity

Rates of serum aminotransferase elevations during low dose, chronic ibuprofen therapy are comparable to those that occur with placebo controls (0.4%). However, higher rates of ALT elevations occur with high, full doses of 2,400 to 3,200 mg daily (up to 16%). Generally, ALT elevations are mild and rarely above 100 U/L. Rare instances of drug fever arise within 1 to 4 weeks of starting ibuprofen which can be accompanied by serum aminotransferase elevations. If ibuprofen is continued in these situations, more severe liver injury and jaundice may arise. These outcomes may account for a rare case of hepatocellular injury attributed to conventional doses of ibuprofen.

Ibuprofen overdose (>5-10 grams) is characterized by onset of agitation, nausea and vomiting, and stupor 3 to 6 hours after ingestion and with higher dose, followed by coma, respiratory depression, renal dysfunction, and lactic acidosis which can be fatal. While many cases of ibuprofen overdose have not been accompanied by prominent liver injury or jaundice, recently, clear cut cases of acute liver injury resembling the acute hepatic necrosis that occurs with ischemia or acetaminophen overdose have been reported after intentional and unintentional overdoses. The injury arises 2 to 4 days after the overdose and is characterized by a rapid rise in serum aminotransferase levels (typically AST greater than ALT) accompanied by elevations in INR, and delayed increase in bilirubin levels. Serum aminotransferase levels fall rapidly thereafter and are usually normal or near normal within 2 to 4 weeks. Deaths have been reported but generally as a result of medical complications. The liver injury associated with ibuprofen overdose is probably a direct toxicity but its etiology has not been clearly defined.

Idiosyncratic, clinically apparent liver injury due to ibuprofen is very rare (estimated to occur at a rate of 1.0-1.6 cases per 100,000 prescriptions and in 1 per 10,000 new users). However, many convincing reports have been published of acute liver injury attributed to ibuprofen, usually after presentation with an immunoallergic-like reaction within days of starting (Cases 1 and 2). Some instances are associated with severe hypersensitivity reactions, such as DRESS syndrome, Stevens Johnson syndrome (SJS) or toxic epidermal necrolysis (TEN) typically with a mixed or cholestatic pattern of liver injury. The time to onset is within a few days to 3 weeks of starting, occasional cases arising after 3 to 6 weeks. Immunoallergic features are prominent (fever, rash, eosinophilia, facial edema, lymphadenopathy). Most cases are mild-to-moderate in severity and rapidly reversible on stopping ibuprofen. Rare instances of cholestatic liver injury due to ibuprofen are followed by severe, protracted cholestasis, vanishing bile duct syndrome, and chronic liver failure (Case 3). Idiosyncratic liver injury due to ibuprofen is typically seen in patients taking rather high daily doses and can occur abruptly in patients who restart ibuprofen have tolerated therapy in the past.

The appearance of clinically apparent liver injury during long term or intermittent, low dose ibuprofen therapy has not been convincingly demonstrated. Some instances of liver injury from ibuprofen have arisen in patients on long-term, low-dose or intermittent therapy who increase the dose to high levels (at least 1,200 mg daily). However, ibuprofen is a commonly used analgesic and acute liver injury of unclear cause can be falsely attributed to low dose or intermittent use of ibuprofen which is sometimes started at the onset of the incidental illness such as herpes zoster or viral or bacterial pharyngitis.

Likelihood score: A (well defined but very rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanisms of ibuprofen induced liver injury are not clearly known. The abrupt very hepatocellular injury is probably direct hepatotoxicity and occurs most frequently in patients with comorbidities such as chronic liver disease, alcoholism, malnutrition, or polypharmacy. The rapid onset suggests a toxic metabolic byproduct. Cases with signs and symptoms of hypersensitivity, in contrast, are most likely idiosyncratic and immunologically mediated.

### Outcome and Management

The severity of the liver injury from ibuprofen ranges from asymptomatic elevations in serum aminotransferase levels, to acute cholestatic hepatitis, to acute liver failure and the need for transplantation. Several instances of chronic vanishing bile duct syndrome have followed apparent immune-allergic, cholestatic hepatitis attributed to ibuprofen. In contrast, the acute liver failure associated with ibuprofen follows the pattern of acute hepatic necrosis due to higher doses of ibuprofen. However, in most instances of both the cholestatic and hepatocellular injury linked to ibuprofen complete recovery occurs within weeks to several months after stopping the drug. Reexposure to ibuprofen after immune-allergic liver injury usually leads to recurrence of the hepatic injury and should be avoided. There is little information on cross sensitivity to liver injury among the various NSAIDs, but it is probably prudent to avoid the other propionic acid forms (naproxen, oxaprozin, fenoprofen among others) and to monitor patients carefully who start other forms of NSAIDs.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORTS

### Case 1. Acute hepatic injury attributed to ibuprofen.(1)

A 59 year old woman was treated with ibuprofen (600 mg three times daily) for hip pain and developed jaundice and fatigue 5 days later. Ibuprofen was continued and her symptoms progressed. She was admitted to a referral hospital and the medication was stopped ten days after starting ibuprofen. She had no fever or rash. She denied a history of previous liver disease, risk factors for viral hepatitis, alcohol abuse or exposure to any other medications. Laboratory results showed marked elevations in serum aminotransferase levels, total bilirubin of 20 mg/dL, and prothrombin time [PT] 61% (Table). Tests for hepatitis A, B and C and other viruses were negative as were autoantibodies. Ceruloplasmin levels were normal. She continued to do poorly and developed ascites and renal dysfunction. She underwent successful liver transplantation 10 weeks after onset. The liver showed submassive hepatic necrosis.

#### Key Points

Medication: | Ibuprofen (1800 mg daily)
Pattern: | Hepatocellular (R=17.9)
Severity: | 5+ (jaundice, hospitalization, hepatic failure, liver transplantation)
Latency: | 5 days
Recovery: | Acute liver failure requiring liver transplantation
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | 0 | Ibuprofen started (1.8 g/d) for hip pain
5 | 0 | Jaundice, dark urine & fatigue, no rash or fever
10 days | 0 | 2089 | 1550 | 737 | 20 | Ibuprofen stopped, PT 61%
24 days | 14 days | 2099 | 2260 | | 30 | PT 46%, creatinine 1.4 mg/dL
6 weeks | 1 month | | | | | Ascites and liver failure
10 weeks | 2 months | | | | | Liver transplantation
Normal Values | | <45 | <35 | <280 | <1.2

#### Comment

Clinically apparent hepatic injury from ibuprofen is rare, but it can be severe, and several cases of ibuprofen related acute liver failure leading to death or need for liver transplantation have been described. Typical in this case was the abrupt onset of injury within a week of starting high therapeutic doses of ibuprofen (1.8 grams daily). Continuation of the medication for 5 days despite symptoms of jaundice may have contributed to the severity of the outcome. The absence of other causes for the acute liver failure and the appearance within days of starting ibuprofen in a patient on no other medication is in favor of the drug causing the injury. The biochemical findings suggest acute hepatitis necrosis rather than a viral hepatitis like course and direct rather that idiosyncratic or immune mediated hepatotoxicity.

### Case 2. Stevens Johnson syndrome and acute hepatic injury from ibuprofen.(2)

A 44 year old man was given ibuprofen (400 mg three times daily) for traumatic knee pain for 8 days, and within hours of restarting ibuprofen one week later developed skin rash, fever, and severe sore throat. He was seen in an emergency room and started on penicillin for suspected scarlatina, but throat cultures were negative and the patient continued to have high fevers and worsening rash. Two days later he was admitted with high fever, extensive rash with involvement of the conjunctiva, nose, mouth, and throat, cervical lymphadenopathy and jaundice. He had no history of viral hepatitis or high risk behaviors or alcohol abuse. Serum testing revealed serum bilirubin of 16.6 mg/dL, ALT 104 U/L, and alkaline phosphatase of 135 U/L (Table). Multiple bacterial cultures were negative. Tests for hepatitis B and mononucleosis were negative. He developed mild eosinophilia (5% and 12%). Because of the diagnosis of probable Stevens Johnson syndrome, he was started on corticosteroids. He improved slowly and corticosteroids were tapered and eventually discontinued 5 months later. Liver tests gradually improved and were normal during follow up.

#### Key Points

Medication: | Ibuprofen (400 mg single dose; re-exposure)
Pattern: | Cholestatic (R=0.8)
Severity: | 4+ (hospitalized, jaundice, severe Stevens Johnson syndrome)
Latency: | 2 days
Recovery: | Approximately 6 months
Other medications: | Penicillin

#### Laboratory Values

Time After Restarting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comment
-15 days | 0 | Starts 8 day course of ibuprofen (400 mg three times daily)
0 | 0 | Single 400 mg dose of ibuprofen
3 days | 3 days | 104 | 135 | 16.6 | Eosinophilia: 5%
4 days | 4 days | 112 | 177 | 17.9 | Eosinophilia: 12%. Corticosteroids started
7 days | 7 days | 441 | 238 | 14.1 | Corticosteroid therapy (iv)
2 weeks | 2 weeks | 220 | 150 | 6.3 | Corticosteroid therapy (iv)
3 weeks | 3 weeks | 140 | 115 | 3.1 | Switched to oral prednisone
4 weeks | 4 weeks | 153 | 76 | 2.4
7 weeks | 7 weeks | 97 | 31 | 1.7
10 weeks | 10 weeks | 70 | 26 | 1.4
3 months | 3 months | 45 | 25 | 0.9 | Prednisone stopped
6 months | 6 months | 31 | 30 | 1.0
Normal Values | | <45 | <45 | <1.2

#### Comment

Stevens Johnson syndrome is a known complication of many medications including the NSAIDS. Some cases are accompanied by hepatic injury, which is typically cholestatic and can be severe and prolonged. This patient required corticosteroid therapy for the hypersensitivity response which may or may not have benefited the hepatic injury. Full recovery required 4 to 6 months.

### Case 3. Vanishing bile duct syndrome after acute cholestatic injury attributed to ibuprofen.(3)

A 29 year old man with history of multiple allergies developed jaundice and abdominal pain 3 weeks after starting low doses of ibuprofen (600 mg/day) for nonspecific body aches. He was admitted with the suspected diagnosis of cholangitis, and ibuprofen was stopped. Serum bilirubin was 6.5 mg/dL and both ALT and alkaline phosphatase were moderately elevated (Table). He had no risk factors for viral hepatitis and denied alcohol abuse. Serologic tests for hepatitis A, B and C were negative as were autoantibodies including ANA and AMA. Ultrasound of the abdomen showed no evidence of gallstones or biliary obstruction. He was treated with antibiotics, but jaundice worsened and he developed pruritus. A liver biopsy showed intrahepatic cholestasis, marked portal inflammatory infiltrates with damage to and reduced numbers of bile ducts. Endoscopic retrograde cholangiopancreatography was normal. A course of corticosteroids had no apparent effect, and serum bilirubin levels continued to rise. A second liver biopsy 6 weeks after onset showed less portal inflammation, but worsening cholestasis and further decrease in numbers of small bile ducts. Therapy for pruritus included antihistamines, ursodiol and cholestyramine with only modest effect. A third liver biopsy at 6 months showed markedly reduced bile ducts ("ductopenia"). At 12 months, he continued to be deeply jaundiced and was symptomatic with marked pruritus and xanthomata. He was referred for liver transplantation.

#### Key Points

Medication: | Ibuprofen (600 mg daily)
Pattern: | Initially mixed (R=4.5), later cholestatic (R=<1.0)
Severity: | 4+ (jaundice, hospitalization, progressive hepatic failure)
Latency: | 3 weeks
Recovery: | No. Jaundice and vanishing bile duct syndrome one year later
Other medications: | Allergy injections for six weeks before onset

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin (mg/dL) | Comment
0 | | Ibuprofen started (600 mg daily)
3 weeks | 0 | 488 | 309 | 6.5 | Ibuprofen stopped
5 weeks | 2 weeks | 400 | 2151 | 11.9 | Liver biopsy, ERCP
7 weeks | 4 weeks | 150 | 750 | 24.0
4 months | 3 months | 300 | 1000 | 21.0 | Second liver biopsy
6 months | 5 months | 180 | 850 | 16.5
8 months | 7 months | 140 | 4000 | 19.0 | Third liver biopsy
10 months | 9 months | 200 | 900 | 8.0
1 year | 11 months | 300 | 3000 | 13.0 | Sent for liver transplant
Normal Values | | <41 | <115 | <1.2

* Some values estimated from Figure 1.

#### Comment

Cases of acute cholestatic liver injury from ibuprofen are very rare. This case was associated with a low dose of ibuprofen and a latency of 3 weeks to the onset of acute cholestatic hepatitis that evolved into chronic cholestasis and the vanishing bile duct syndrome. On the first determinations, the serum enzyme pattern was “mixed”, but it rapidly became distinctly cholestatic, matching the symptoms of deep jaundice and pruritus as well as the liver biopsy that showed marked cholestasis with scant hepatocellular injury. The prolonged course and rapid onset combined with a history of allergies points towards an immune-allergic mechanism for this reaction. The patient had a decreased number of bile ducts on initial liver biopsy, which became progressively fewer on follow up biopsies, thus demonstrating the progressive nature of “vanishing bile duct syndrome.” This outcome occurred despite prompt discontinuation of ibuprofen. The course of vanishing bile duct syndrome is variable, some patients eventually recover, but it can be unremitting, severe, leading–as in this case–to the need for liver transplantation or death.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ibuprofen – Generic, Motrin®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ibuprofen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Ibuprofen | 15687-27-1 | C13-H18-O2

## CITED REFERENCES

1 Rodríguez-Gonzáles FJ, Montero JL, Puente J, et al. Orthotopic liver transplantation after subacute liver failure induced by therapeutic doses of ibuprofen. Am J Gastroenterol 2002; 97: 2476-7.12358284
2 Sternlieb P, Robinson RM. Stevens-Johnson syndrome plus toxic hepatitis due to ibuprofen. N Y State J Med 1978; 78: 1239-43.276660
3 Alam I, Ferrell LD, Bass NM. Vanishing bile duct syndrome temporally associated with ibuprofen use. Am J Gastroenterol 1996; 91: 1626-30.8759674

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2025

Abbreviations used: NSAID, nonsteroidal anti-inflammatory drug; SJS, Stevens Johnson syndrome; TEN, toxic epidermal necrolysis; DRESS, drug reaction with eosinophilia and systemic symptoms; VBDS, vanishing bile duct syndrome; COX-1 and -2, cyclooxygenase 1 and 2.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-553 (Expert review of hepatotoxicity published in 1999; ibuprofen is one of the least likely NSAIDs to cause hepatotoxicity, but both hepatocellular and cholestatic liver injury has been reported with its use).
Lewis JH, Stine AG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd. Amsterdam: Elsevier, 2013, pp. 369-401 (Review of hepatotoxicity of NSAIDs published mentions that ibuprofen is one of the best tolerated NSAIDs but has been linked to rare instances of clinically apparent liver injury including acute liver failure and vanishing bile duct syndrome).
Grosser T, Smyth E, FitzGerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 685-709 (Textbook of pharmacology and therapeutics; ibuprofen is a propionic acid derivative, the first of its class and the most commonly used NSAID in the U.S.; it should be given three or four times daily).
Gasparetto P. Un caso di ittero eptaocellulare in corso di trattamento con ibuprofin [A case of hepatocellular jaundice during treatment with ibuprofen] Minerva Pediatr 1974; 26: 531-3. Italian. PMID: 4827607 (5 year old with juvenile rheumatoid arthritis developed fatigue and jaundice 17 days after starting ibuprofen [bilirubin 3.3 mg/dL, ALT 142 U/L, AST 259 U/L]; resolution in 7 days).
Mandell B, Shen HS, Hepburn B. Letter: Fever from ibuprofen in a patient with lupus erythematosus. Ann Intern Med 1976; 85: 209-10. PMID: (36 year old woman with systemic lupus erythematosus developed fever after 1 week of ibuprofen [2000 mg/day] followed by nausea and AST 147 U/L, no mention of jaundice, recurrence of fever on rechallenge 3 times). 942146
Bravo JF, Jacobson MP, Mertens BF. Fatty liver and pleural effusion with ibuprofen therapy. Ann Intern Med 1977; 87: 200-1. (48 year old woman with connective tissue disease died in respiratory failure and shock; found to have fatty liver on autopsy which was attributed to ibuprofen; role of ampicillin and cephalexin-allergic reactions unclear). 889204
Stempel DA, Miller JJ 3rd. Lymphopenia and hepatic toxicity with ibuprofen. J Pediatr 1977; 90: 657-8. (12 year old girl with juvenile rheumatoid arthritis developed fever, arthralgias and fatigue 2 to 3 weeks after starting ibuprofen [bilirubin 1 mg/dL, ALT 1245 U/L]; fever resolving in 1 day and liver abnormalities within 2 weeks of stopping). 839391
Sonnenblick M, Abraham AS. Ibuprofen hypersensitivity in systemic lupus erythematosus. Br Med J 1978; 1: 619-20. (2 women, ages 15 and 54 years, developed fever and rash 6 and 10 days after starting ibuprofen [bilirubin normal, AST 185 and 105 UL]; resolving within one week of stopping; one having recurrence of fever within hours of a single dose [AST 105 U/L]). 630258
Sternlieb P, Robinson RM. Stevens-Johnson syndrome plus toxic hepatitis due to ibuprofen. N Y State J Med 1978; 78: 1239-43. (44 year old man developed Stevens-Johnson syndrome within hours of restarting ibuprofen [after an 8-day course a week before] with subsequent jaundice [bilirubin 16.6 mg/dL, ALT 104 U/L, Alk P 135 U/L]; resolving with prednisone therapy over next 3 months. Authors mention that 14 cases of hepatic injury were on file with sponsor: Case 2). 276660
Kantor TG. Ibuprofen. Ann Intern Med 1979; 91: 877-82. (Review of ibuprofen after 5 years use in U.S., mentions that there have been isolated reports of hepatotoxicity). 391117
Sternlieb P, Robinson RM. Side effects of ibuprofen. Ann Intern Med 1980; 92: 570. (Letter in response to Kantor article, mentioning their case of Stevens-Johnson syndrome after ibuprofen: Sternlieb [1978]). 6444790
Hunt DP, Leigh RJ. Overdose with ibuprofen causing unconsciousness and hypotension. Br Med J. 1980;281(6253):1458-9.. (70 year old man developed coma and hypotension within 1-2 hours of ingesting 12 g of ibuprofen, with serum levels of 840 mg/L [normal 20-30 mg/L], no further follow up provided). 7437834
Court H, Streete P, Volans GN. Acute poisoning with ibuprofen. Hum Toxicol. 1983;2:381-4.. (The UK National Poisons Information Service received 58,00 poisoning reports during a 2-year period, including 75 cases for ibuprofen overdose, most patients [36 children, 39 adults] had no or only mild symptoms of nausea, vomiting, and drowsiness; drug levels showed concentrations of up to 704 mg/L could be tolerated without ill effects; only 3 patients had severe outcomes and only one patient died, a 67 year old woman who became hypotensive, comatose, and died of cardiac collapse within 4 hours). 6862484
Royer GL, Seckman CE, Welshman IR. Safety profile: fifteen years of clinical experience with ibuprofen. Am J Med 1984; 77: 25-34. (Review of safety studies of ibuprofen : clinically apparent injury is rare; high doses [2400-3200 mg/day] may cause ALT elevations in 16% [all <100 U/L] but less commonly than aspirin). 6235745
Johnson JH, Jick H, Hunter JR, Dickson JF. A follow-up study of ibuprofen users. J Rheumatol 1985; 12: 549-52. (Retrospective study of 13,320 members of HMO in Seattle who had a prescription filled for ibuprofen between 1977 and 1982 and then were hospitalized with a possible complication; 7 cases identified but none were hepatic and none considered even probably related). 4045852
Bennett RR, Dunkelberg JC, Marks ES. Acute oliguric renal failure due to ibuprofen overdose. South Med J. 1985;78:490-1.. (52 year old woman developed nausea within hours of an ibuprofen overdose [54 g] and at 36 hours had lactic acidosis and worsening renal function [creatinine 4.6 rising to 8.8 mg/dL], yet with complete recovery with medical support over the following 2-3 weeks; no mention of liver injury). 3983674
Lee CY, Finkler A. Acute intoxication due to ibuprofen overdose. Arch Pathol Lab Med. 1986;110(8):747-9.. (Adult male who ingested an overdose of ibuprofen [20 g] was unresponsive and had serum ibuprofen levels of 185 mg/L at 10 hours, and then developed worsening metabolic acidosis, renal failure, acute liver injury, cholestasis and thrombocytopenia, but with medical management recovered fully). 3755329
Hall AH, Smolinske SC, Conrad FL, Wruk KM, Kulig KW, Dwelle TL, Rumack BH. Ibuprofen overdose: 126 cases. Ann Emerg Med. 1986;15:1308-13.. (Among 126 cases of ibuprofen overdose [0.2 to 17 g; 88 children and 38 adults] reported to the Rocky Mountain Poison and Drug Center during 1984 and 1985, only 19 developed symptoms, mostly mild neurologic depression or gastrointestinal upset; 2 children had seizures one of whom died; a nomogram based upon serum concentration by time after overdose suggested that levels above 200 μg/mL at one hour were indicative of potential toxicity; elimination half-life was 1.5 hours but was delayed by renal dysfunction). 3777588
Lee CY, Finkler A. Acute intoxication due to ibuprofen overdose. Arch Pathol Lab Med 1986; 110: 747-9. (Overdose of 20 g of ibuprofen led to metabolic acidosis, renal dysfunction, peak AST 291 U/L, LDH 104 U/L, Alk P 245 U/L but no mention of jaundice; resolved over next 10 days). 3755329
Hall AH, Smolinske SC, Conrad FL, Wruk KM, Kulig KW, Dwelle TL, Rumack BH. Ibuprofen overdose: 126 cases. Ann Emerg Med 1986; 15: 1308-13. (Among 126 patients with ibuprofen overdose, symptoms developed in 24 [19%] including CNS depression, seizures, bradycardia, hypotension, apnea, and renal dysfunction arising at least 4 hours after ingestion with poor correlation of severity of outcome with reported amount taken; no mention of liver injury or jaundice). 3777588
Perry SJ, Streete PJ, Volans GN. Ibuprofen overdose: the first two years of over-the-counter sales. Human Toxicol 1987; 6: 173-8. (Prospective survey of ibuprofen overdoses during first 2 years of over-the-counter availability in the UK found 203 cases, but most were asymptomatic or mild and none were associated with evidence of hepatic injury [one patient had peak AST value of 38 U/L]). 3557476
Hall AH, Smolinske SC, Kulig KW, Rumack BH. Ibuprofen overdose--a prospective study. West J Med. 1988;148:653-6.. (Among 45 cases of acute ibuprofen overdose [39 children and 6 adults] reported to the Rocky Mountain Poison and Drug Center in 1985 and 1986, only 7 developed clinical apparent toxicity including nausea, abdominal cramps, tachycardia, coma, apnea, metabolic acidosis, and renal failure; the only death was in an adult who ingested 24 gm and died after two days with oliguric renal failure and sepsis). 3176471
Hall AH, Smolinske SC, Kulig KW, Rumack BH. Ibuprofen overdose--a prospective study. West J Med 1988; 148: 653-6. (Among 61 cases of ibuprofen overdose reported to a regional poison control center, symptoms developed in 7 [16%] and one adult died; no one became ill with dose of less than 104 mg/kg; no mention of hepatic injury). 3176471
Freeland GR, Northington RS, Hedrich DA, Walker BR. Hepatic safety of two analgesics used over the counter: ibuprofen and aspirin. Clin Pharmacol Ther 1988; 43: 473-9. (Analysis of database on 1468 patients with arthritis given ibuprofen, oxaprozin or aspirin; AST elevations occurred in 6% on ibuprofen, 12% oxaprozin and 13% aspirin, but none were considered drug-related or >3 times ULN). 3365912
Hannequin JR, Doffoel M, Schmutz G. Hépatite secondaire aux anti-inflammatoires non stéroïdiens actuels [Hepatitis secondary to current non-steroidal anti-inflammatory agents]. Rev Rhum Mal Osteoartic 1988; 55: 983-8. French. PMID: 3070713 (Analysis of 83 cases of NSAID-related liver injury reported in the literature, including 28 attributed to ibuprofen which tended to have immunoallergic features and mixed pattern of injury with two deaths and one case of Stevens Johnson syndrome).
Kromann-Andersen H, Pedersen A. Reported adverse reactions to and consumption of nonsteroidal anti-inflammatory drugs in Denmark over a 17-year period. Dan Med Bull. 1988; 35: 187-92. (In Denmark, 3% of all spontaneous reports of adverse events from NSAIDs were hepatic [n=405], 3% of which were fatal). 2966038
Menzies DG, Conn AG, Williamson IJ, Prescott LF. Fulminant hyperkalaemia and multiple complications following ibuprofen overdose. Med Toxicol Adverse Drug Exp. 1989;4:468-712601619 (17 year old adolescent male developed coma after an ibuprofen overdose with metabolic acidosis, tachycardia, hyperkalemia, fever, respiratory failure, and renal dysfunction but ultimately recovered). 2601619
McElwee NE, Veltri JC, Bradford DC, Rollins DE. A prospective, population-based study of acute ibuprofen overdose: complications are rare and routine serum levels not warranted. Ann Emerg Med 1990; 19: 657-62. (Among 329 cases of ibuprofen overdose reported to a regional poison center during a one-year period shortly after it became available over-the-counter; CNS symptoms developed in 30% of patients with poor correlation of symptoms with serum concentrations; no mention of liver injury). 2188537
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroidal drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-38. (Review of NSAID related and other forms of drug induced liver injury). 2281340
McElwee NE, Veltri JC, Bradford DC, Rollins DE. A prospective, population-based study of acute ibuprofen overdose: complications are rare and routine serum levels not warranted. Ann Emerg Med. 1990;19:657-62. (Among 329 cases of ibuprofen overdose reported to the Intermountain Regional Poison Control Center, only 50% were symptomatic, 34% had minor symptoms, 16% had moderate-severe symptoms, and only one patient died). 2188537
Goodwin SD, Glenny RW. Nonsteroidal anti-inflammatory drug-associated pulmonary infiltrates with eosinophilia. Review of the literature and Food and Drug Administration Adverse Drug Reaction reports. Arch Intern Med. 1992;152:1521-4. (68 year old man with osteoarthritis developed cough and dyspnea on exertion accompanied by eosinophilia [1470/μL] and upper lobe pulmonary infiltrates that resolved within weeks of stopping naproxen, later admitting to 3 previous episodes that followed within a few weeks of starting naproxen; review of literature and FDA database revealed at least 20 further naproxen related cases). 1627033
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Among 1100 cases of drug-induced liver injury reported between 1978 and 1987 in Denmark, 17 cases were attributed to ibuprofen: 4 with ALT elevations only, 8 hepatocellular, 4 cholestatic and 2 fatal). 1506809
Halpern SM, Fitzpatrick R, Volans GN. Ibuprofen toxicity. A review of adverse reactions and overdose. Adverse Drug React Toxicol Rev. 1993;12:107-28. (Review of toxicity of ibuprofen based on reports of overdose as well as adverse reactions to therapeutic use focusing upon gastrointestinal, cutaneous, central nervous system, ocular, and hepatic effects which are rare but can be severe and even fatal). 8357944
Downie A, Ali A, Bell D. Severe metabolic acidosis complicating massive ibuprofen overdose. Postgrad Med J. 1993;69:575-7. (33 year old man developed coma with 10 hours of taking 60 gm of ibuprofen with hypotension, lactic acidosis, renal dysfunction, and pulmonary infiltrates, recovering within the next few weeks). 8415347
Vigouroux C, Fitoussi D, Cariou D, Aerts J, Pasquier P. [Disclosure of systemic lupus erythematosus in a case of hepatitis caused by ibuprofen] Rev Med Interne 1993; 14: 856-9. French. PMID: 8191104 (32 year old woman with systemic lupus erythematosus developed rash, fever and anicteric hepatitis [bilirubin normal, ALT 370 U/L; Alk P normal] 4 weeks after starting ibuprofen; hepatitis resolved without further treatment of lupus).
García Rodríguez LA, Williams R, Derby LE, Dean AD, Jick H. Acute liver injury associated with nonsteroidal anti-inflammatory drugs and the role of risk factors. Arch Intern Med 1994; 154: 311-6. (Population based study of 625,307 UK subjects who received at least one prescription for 1 of 12 NSAIDs, among whom 35 subsequently had liver injury: 12 with abnormal liver tests only, 23 with acute symptomatic injury [ibuprofen in 5]; incidence was 1.6/100,000 ibuprofen users, ibuprofen had lowest rate among NSAIDs but accounted for the most cases because of the frequency of its use). 8297198
Le HT, Bosse GM, Tsai Y. Ibuprofen overdose complicated by renal failure, adult respiratory distress syndrome, and metabolic acidosis. J Toxicol Clin Toxicol. 1994;32:315-20. (23 year old man developed nausea and abdominal cramps within 5 hours of an overdose of 30 g of ibuprofen [hypokalemia and metabolic acidosis] followed 3 days later by oliguric renal failure requiring dialysis and hypoxia requiring ventilation, gradually improving to normal within the next 3-5 weeks). 8007040
Wolfe TR. Ibuprofen overdose. Am J Emerg Med. 1995;13:375. (44 year old man developed drowsiness, anxiety, and hypotension within 12 hours of an overdose of ibuprofen [72 g] with lactic acidosis, hyperkalemia, all of which resolved with medical care; liver tests were normal at onset). 7755839
Zuckerman GB, Uy CC. Shock, metabolic acidosis, and coma following ibuprofen overdose in a child. Ann Pharmacother 1995; 29: 869-71. (6 year old boy took an overdose of ibuprofen [30 tablets, 6 g] and developed shock, coma and metabolic acidosis successfully treated with mechanical ventilation and fluids; liver enzymes were "unremarkable"). 8547735
Lesko SM, Mitchell AA. An assessment of the safety of pediatric ibuprofen. A practitioner-based randomized clinical trial. JAMA 1995; 273: 929-33. (Among 55,000 children in a prospective controlled trial who were given ibuprofen or acetaminophen for fever, no child developed Reye syndrome or clinically apparent liver injury). 7884951
Alam I, Ferrell LD, Bass NM. Vanishing bile duct syndrome temporally associated with ibuprofen use. Am J Gastroenterol 1996; 91: 1626-30. (29 year old man developed acute cholestatic hepatitis followed by vanishing bile duct syndrome after a 3-week course of ibuprofen: Case 3). 8759674
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. (Review of population based studies of NSAID use and hepatic injury; frequency of clinically apparent liver injury from NSAIDs was ~10 cases per 100,000 patient-years of use, ranging from 6 to 13 per 100,000 for ibuprofen) 9041931
Riley TR 3rd, Smith JP. Ibuprofen-induced hepatotoxicity in patients with chronic hepatitis C: a case series. Am J Gastroenterol 1998; 93: 1563-5. (Three patients with chronic hepatitis C developed marked ALT elevations [1209, 1238 and 1577 U/L] while on ibuprofen 1600-2400 mg for short periods, no mention of symptoms or jaundice, resolving rapidly upon stopping). 9732947
Srivastava M, Perez-Atayde A, Jonas MM. Drug-associated acute-onset vanishing bile duct and Stevens-Johnson syndromes in a child. Gastroenterology 1998; 115: 743-6. (9 year old girl developed Stevens Johnson syndrome 3 days after her 2nd exposure to ibuprofen [bilirubin 3.3 mg/dL, ALT 649 U/L, Alk P 649 U/L], and subsequent progressive jaundice, biopsy showing bile duct damage and loss of bile ducts, with severe cholestasis despite trials of prednisone and tacrolimus). 9721172
Ritter A, Eskin B. Ibuprofen overdose presenting with severe agitation and hypothermia. Am J Emerg Med. 1998;16:549-50. (16 year old boy was found unresponsive shortly after taking an overdose of ibuprofen [20 g] and had hypotension, hypothermia, agitation, and lactic acidosis, with transiently and mildly abnormal liver tests [ALT 59 U/L, AST 50 U/L, Alk P 163 U/L, bilirubin not reported] and full recovery within a few days). 9725984
Mayoral W, Lewis JH, Zimmerman H. Drug-induced liver disease. Curr Opin Gastroenterol 1999; 15: 208-16. (Review article with paragraph on effects of ibuprofen in hepatitis C and its link to vanishing bile duct syndrome). 17023947
Pérez-Gutthann S, García-Rodríguez LA, Duque-Oliart A, Varas-Lorenzo C. Low-dose diclofenac, naproxen, and ibuprofen cohort study. Pharmacotherapy 1999; 19: 854-9. (Post-marketing study of 46,919 patients on naproxen, 54,830 on ibuprofen, 22,146 on diclofenac; found 3 cases of liver injury, one with naproxen and two with ibuprofen, giving an estimated frequency of ~1/10,000 users). 10417034
Laurent S, Rahier J, Geubel AP, Lerut J, Horsmans Y. Subfulminant hepatitis requiring liver transplantation following ibuprofen overdose. Liver 2000; 20: 93-4. (55 year old woman took an overdose of ibuprofen [9.6 g] and developed jaundice 8 days later [bilirubin 10.2 mg/dL, ALT 1767 U/L, Alk P 375 U/L], progressing to hepatic failure and liver transplantation 3 weeks later; patient was a chronic alcoholic but explant showed massive collapse). 10726966
Seifert SA, Bronstein AC, McGuire T. Massive ibuprofen ingestion with survival. J Toxicol Clin Toxicol. 2000;38(1):55-7. (15 year old girl was found unconscious after a massive overdose of ibuprofen [100 g] and on hospital admission had hypotension and metabolic acidosis but had normal liver and kidney test results improving after temporary ventilation and medical therapy, not developing renal dysfunction or gastrointestinal bleeding, and recovering within 3 days). 10696926
Borel I, Hedelius F, Baumgartner C, Vial T, Scoazec JY, Dumortier J. Hépatite aiguë sévère associée au traitement à l'ibuprofène [Severe acute hepatitis associated with ibuprofen treatment] Gastroenterol Clin Biol 2001; 25: 430-2. French. PMID: 11449133 (66 year old woman developed rash 5 days after starting ibuprofen, followed by jaundice [bilirubin 32 mg/dL, ALT 70 times ULN, Alk P 2.5 times ULN, ANA positive], with liver biopsy showing fibrosis and clinical response to prednisone, not relapsing when corticosteroids stopped).
Hernández-Díaz S, García-Rodríguez LA. Epidemiologic assessment of the safety of conventional nonsteroidal anti-inflammatory drugs. Am J Med 2001; 110 (Suppl 3A): 20S-7S. (Review of safety of NSAIDS; acute liver injury rare ~9 cases/100,000 users/year; no increased risk with prolonged therapy and may be more common with rheumatoid arthritis than other indications). 11173046
Morelli MS, O'Brien FX. Stevens-Johnson Syndrome and cholestatic hepatitis. Dig Dis Sci 2001; 46: 2385-8. (19 year old female developed mild hepatitis [bilirubin 3.3 mg/dL, ALT 373 U/L] after 3 days of ketorolac and metoclopramide therapy, also given ibuprofen 5 days before; patient then developed Stevens-Johnson syndrome after cephalosporin therapy). 11713940
Andrade RJ, Lucena MI, García-Cortés M, García-Ruiz E, Fernández-Bonilla E, Vázquez L. Chronic hepatitis C, ibuprofen, and liver damage. Am J Gastroenterol 2002; 97: 1854-5. (57 year old woman with chronic hepatitis C given ibuprofen [1200 mg/day] for 30 days, developed asymptomatic ALT rise from 130 to 1093 U/L, GGT from 41 to 355 U/L with no other obvious cause). 12135061
Javier Rodríguez-González F, Montero JL, Puente J, Fraga E, Costan G, Barrera P, Muntane J, et al. Orthotopic liver transplantation after subacute liver failure induced by therapeutic doses of ibuprofen. Am J Gastroenterol 2002; 97: 2476-7. (59 year old woman developed jaundice 5 days after starting ibuprofen [bilirubin 20 mg/dL, ALT 2089 U/L; Alk P 737 U/L], progressing to hepatic failure and liver transplant 10 weeks later; explant showed submassive necrosis: Case 1). 12358284
Traversa G, Bianchi C, Da Cas R, Abraha I, Menniti-Ippolito F, Venegoni M. Cohort study of hepatotoxicity associated with nimesulide and other non-steroidal anti-inflammatory drugs. BMJ 2003; 327: 18-22. (Among 397,537 patients who received a prescription for an NSAID [770,000 person years] between 1997 and 2002, 42 developed an acute non-viral hepatitis including 2 of 4482 receiving ibuprofen). 12842950
Volans G, Monaghan J, Colbridge M. Ibuprofen overdose. Int J Clin Pract Suppl. 2003;(135):54-60. (Among 1033 patient enquires about ibuprofen overdose made to the UK National Poisons Information Service, most patients had no or only mild symptoms and reported fatal cases usually had “complicating factors”). 12723749
Lee YD, Cho YS, Han MS, Rhee YK. Ibuprofen-induced eosinophilic pneumonia. Hosp Med. 2004r;65:241. (25 year old man developed cough, fever, chest pain and multiple pulmonary infiltrates with peripheral eosinophilia [14,500/μL] arising 7 days after starting ibuprofen for headaches; patient having had 2 such episodes in the past temporally related to ibuprofen ). 15127682
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Population based study of 1.6 million persons in UK and 128 valid cases of drug-induced liver disease, found odds ratio for liver injury to be 4.1 for diclofenac but 0.4 for all other NSAIDs [2 cases only]). 15206996
Taghian M, Tran TA, Bresson-Hadni S, Menget A, Felix S, Jacquemin E. Acute vanishing bile duct syndrome after ibuprofen therapy in a child. J Pediatr 2004; 145: 273-6. (10 year old girl developed Stevens-Johnson syndrome after 2 days of ibuprofen for fever [initial bilirubin 5.4 mg/dL, ALT 639 U/L, Alk P 2 times ULN], followed by prolonged jaundice and vanishing bile duct syndrome but ultimate recovery). 15289784
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network found 570 cases of drug-induced liver disease and ibuprofen ranked 4th in number of cases [n=18]; half had mixed, half hepatocellular enzyme elevations; 2 eosinophilia; 2 acute liver failure one undergoing liver transplant and one dying). 16083708
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug-induced acute liver failure: diclofenac and naproxen mentioned in top 20 causes; ibuprofen listed as associated with one case). 16165719
Rostom A, Goldkind L, Laine L. Nonsteroidal anti-inflammatory drugs and hepatic toxicity: a systematic review of randomized controlled trials in arthritis patients. Clin Gastroenterol Hepatol 2005; 3: 489-98. (Review of randomized clinical trial of NSAIDS for frequency of adverse events; ALT >3 times ULN found in 0.43% of 3516 ibuprofen-treated patients with no liver-related serious adverse events or deaths). 15880319
Tyagi P, Sharma BC, Sarin SK. Cholestatic liver injury due to ibuprofen. Indian J Gastroenterol 2005; 24: 77-8. (35 year old man developed rash after one dose of ibuprofen, followed in 7 days by jaundice with subsequent prolonged course, requiring 7 months to resolve; no specifics of laboratory tests given). 15879659
Arellano FM, Yood MU, Wentworth CE, Oliveria SA, Rivero E, Verma A, et al. Use of cyclo-oxygenase 2 inhibitors (COX-2) and prescription non-steroidal anti-inflammatory drugs (NSAIDS) in UK and USA populations. Implications for COX-2 cardiovascular profile. Pharmacoepidemiol Drug Saf 2006; 15: 861-72. PMID: (Survey of NSAID use in UK and USA reported that ibuprofen is most commonly used; major focus of article on Cox-2 use). 17086563
Barreales M, Pérez-Carreras M, Meizoso T, Garrido M, Masedo A, Colina F, Solís JA. Infección por el virus de Epstein-Barr y hepatitis colestásica aguda [Epstein-Barr virus infection and acute cholestatic hepatitis] A Med Interna 2006; 23: 483-6. Spanish. PMID: 17134311 (40 year old man developed typical hepatitis from infectious mononucleosis [atypical lymphocytosis, bilirubin 8.2 mg/dL, ALT 428 U/L, Alk P 541 U/L, IgM anti-EBV positive] and took ibuprofen for the initial symptoms which might have contributed to the subsequent hepatic injury).
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug-induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports [89% from the US]; 21 drugs were associated with >50 cases, including diclofenac [15th in frequency] but not ibuprofen). 16054882
Lapeyre-Mestre M, de Castro AM, Bareille MP, Del Pozo JG, Requejo AA, Arias LM, Montastruc JL, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Survey of adverse drug reaction reports from 1982-2001 included 17 due to ibuprofen from Spain and 174 from France, but at a lower rate than with most NSAIDs). 16867024
Wood DM, Monaghan J, Streete P, Jones AL, Dargan PI. Fatality after deliberate ingestion of sustained-release ibuprofen: a case report. Crit Care. 2006;10:R44. (26 year old woman was found unconscious after taking an overdose of sustained-release ibuprofen [~105 g] and rapidly developed uncontrollable hypotension, metabolic acidosis, and cardiovascular collapse and died within hours despite intensive medical support). 16542487
Marciniak KE, Thomas IH, Brogan TV, Roberts JS, Czaja A, Mazor SS. Massive ibuprofen overdose requiring extracorporeal membrane oxygenation for cardiovascular support. Pediatr Crit Care Med. 2007;8:180-2. (A 14 year old boy was found unresponsive after taking a large overdose of ibuprofen [100 g] and on hospital admission was in coma with an ibuprofen level of 776 ug/m, and progressive metabolic acidosis, renal failure, gastrointestinal bleeding, and hypotension leading to placement on extracorporeal membrane oxygenation [ECMO] for 4 days with eventual full recovery; liver enzymes were said to be elevated during the first 24 hours after admission with no follow up or mention of bilirubin levels). 17273120
Holubek W, Stolbach A, Nurok S, Lopez O, Wetter A, Nelson L. A report of two deaths from massive ibuprofen ingestion. J Med Toxicol. 2007;3:52-5. (Two cases: 17 year old girl and 49 year old man with massive ibuprofen overdoses [200 g and 240 g] developed refractory hypotension and metabolic acidosis and died from multiorgan failure 9 and 3 days after hospital admission; ALT levels at onset were 108 U/L in the first and “unremarkable” in the second). 18072160
Holubek W, Stolbach A, Nurok S, Lopez O, Wetter A, Nelson L. A report of two deaths from massive ibuprofen ingestion. J Med Toxicol 2007; 3: 52-5. (2 cases of fatal overdose of ibuprofen; 17 year old girl and 49 year old man, presented with coma, hypothermia, hypotension and metabolic acidosis after intentional overdose; no mention of liver injury, ALT 83 U/L in one patient). 18072160
Elkrief L, Chryssostalis A, Moachon L, Franck N, Terris B, Chaussade S, Sogni P. Hépatite cholestatique sévère associée au syndrome de Stevens-Johnson après prise d'ibuprofène [Severe cholestatic hepatitis associated with Stevens-Johnson syndrome after taking ibuprofen]. Gastroenterol Clin Biol 2007; 31: 1043-5. French. PMID: 18166906 (37 year old woman developed rash 3 days after starting amoxicillin and ibuprofen which progressed to involve eyes and oral membranes with lymphadenopathy and later jaundice [bilirubin 12.8 mg/dL, ALT 181 U/L, Alk P 386 U/L, 7% atypical lymphocytes] with slow but ultimately complete recovery).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug-induced liver disease in the U.S. collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam, 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen] ). 18955056
Bennett WE Jr, Turmelle YP, Shepherd RW. Ibuprofen-induced liver injury in an adolescent athlete. Clin Pediatr (Phila) 2009; 48: 84-6. (16 year old boy developed jaundice 6 weeks after starting ibuprofen for athletic injury [bilirubin 3.2 rising to 10.1 mg/dL, ALT 65 U/L, Alk P 409 U/L], with prolonged cholestasis but ultimate recovery in 2 months). 18626108
Zaffanello M, Brugnara M, Angeli S, Cuzzolin L. Acute non-oliguric kidney failure and cholestatic hepatitis induced by ibuprofen and acetaminophen: a case report. Acta Paediatr 2009; 98: 903-5. (5 year old child treated for 1-2 days with acetaminophen and ibuprofen for febrile seizures subsequently developed renal [peak creatinine 6.3 mg/dL] and hepatic [peak ALT 1229 U/L] abnormalities without jaundice eventually resolving; not clearly attributable to ibuprofen). 19183124
Hotermans C, Belachew S, Moonen G, Delwaide J. Severe liver dysfunction in a patient with multiple sclerosis: the guilty party is not always the disease-modifying therapy. Mult Scler 2009; 15: 1378-9. (38 year old woman with multiple sclerosis developed abnormal ALT [1788 U/L] while on ibuprofen and beta interferon, enzymes becoming normal with stopping both drugs but rising again with restarting ibuprofen [ALT 749 U/L]). 19965562
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; ibuprofen "is characterized by a high safety profile and very low liver toxicity incidence"). 21128314
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, ibuprofen is not listed among the top 41 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug-induced liver injury of which 7 were due to NSAIDs, including 4 attributed to bromfenac, 2 to diclofenac and 1 to etodolac, but none to ibuprofen). 20949552
Levine M, Khurana A, Ruha AM. Polyuria, acidosis, and coma following massive ibuprofen ingestion. J Med Toxicol 2010; 6: 315-7. (19 year old man took overdose of ibuprofen [450 tablets, 90 g] and developed agitation and tachycardia 3 hours later followed by progressive coma, respiratory failure, and lactic acidosis, improving after 48 hours; mentions mild renal abnormalities but no liver test results provided) 20419362
Lee CH, Wang JD, Chen PC. Increased risk of hospitalization for acute hepatitis in patients with previous exposure to NSAIDs. Pharmacoepidemiol Drug Saf 2010; 19: 708-14. (Analysis of the Taiwanese National Health Insurance database found 4519 cases of hospitalization for acute, non-viral liver injury between 2001-2005, of whom 35 received celecoxib [odds ratio compared to controls 1.92], 19 rofecoxib [1.6], 30 nimesulide [2.3], 580 diclofenac [2.2] and 287 ibuprofen [2.5] within 28 days of admission). 20582911
Nanau RM, Neuman MG. Ibuprofen-induced hypersensitivity syndrome. Transl Res 2010; 155: 275-93. (Review of hypersensitivity adverse events in response to ibuprofen provides brief summaries of 8 cases of liver injury attributed to ibuprofen in the literature commenting on the variability of clinical presentation and liver test abnormalities and evidence of hypersensitivity reactions with rash, DRESS and SJS syndrome as well as vanishing bile duct syndrome). 20478543
Levine M, Khurana A, Ruha AM. Polyuria, acidosis, and coma following massive ibuprofen ingestion. J Med Toxicol. 2010;6:315-7. (19 year old boy took an overdose of ibuprofen [90 g] and initially had normal blood chemistry and only muscle-twitching on examination but within several hours developed stupor, coma, hypothermia, metabolic [lactic] acidosis, polyuria, and required intubation and ventilation for 24 hours, but this as followed by full recovery; no mention of liver test abnormalities). 20419362
Frei MY, Nielsen S, Dobbin MD, Tobin CL. Serious morbidity associated with misuse of over-the-counter codeine-ibuprofen analgesics: a series of 27 cases. Med J Aust. 2010;193:294-6. (Description of 27 Australian adults with misuse of over-the-counter codeine and ibuprofen, most had significant adverse events including gastrointestinal complications [ulcers, hemorrhage, recurred nausea and vomiting], renal failure, and opioid dependence and withdrawal]; no mention of hepatic events). 20819050
Hunter LJ, Wood DM, Dargan PI. The patterns of toxicity and management of acute nonsteroidal anti-inflammatory drug (NSAID) overdose. Open Access Emerg Med. 2011 Jul 6;3:39-48. (Review of the clinical features of severe outcomes of overdose with NSAIDs mentions that transient increases in liver tests have been reported with some NSAIDs including ibuprofen but no mention of acute liver failure). 27147851
Leoz MK, Concejo FB, Fernández JM, Urmeneta JM, Peñuela AM. Hepatitis colestásica inducida por ibuprofeno [Ibuprofen-induced cholestatic hepatitis]. Gastroenterol Hepatol 2011; 34: 660-1. Spanish. PMID: 21621876 (32 year old man developed jaundice and pruritus two weeks after starting ibuprofen [bilirubin 3.8 rising to 19.6 mg/dL, ALT 251 U/L, Alk P 314 U/L], slowly resolving 3 to 5 months after stopping).
Bang D, Shah T, Thakker D, Shah Y, Raval AD. Drug-induced Stevens-Johnson syndrome: case series from tertiary care centre in Gujarat. Pharmacoepidemiol Drug Saf 2012; 21: 384-95. (Prospective study of Stevens Johnson syndrome presenting during a 3 year period at a single referral hospital in India identified 29 cases [7 in children] of which 8 were attributed to antibacterials, 8 NSAIDs [5 ibuprofen, 2 diclofenac, 1 numesulide], 8 anticonvulsants, 2 antiretrovirals, 2 antituberculosis agents and 1 methotrexate). 22374707
Lodise M, De-Giorgio F, Rossi R, d'Aloja E, Fucci N. Acute Ibuprofen intoxication: report on a case and review of the literature. Am J Forensic Med Pathol 2012; 33: 242-6. (51 year old man took an overdose of several medications including ibuprofen and presented within a few hours with fatal coma, hypotension, respiratory failure and metabolic acidosis; autopsy showing hepatic congestion). 22835967
Vogts N, Young S. Pulmonary infiltrates with eosinophilia syndrome in ibuprofen overdose. N Z Med J. 2012;125:74-5. (45 year old woman developed 2 days of drowsiness after an overdose of “Neurofen Plus” tablets [codeine and ibuprofen] with metabolic acidosis, renal dysfunction, and bilateral patchy pulmonary infiltrates with eosinophilia [600/uL] which improved within 5 days and chest X-ray was normal after 4 weeks, an example of PIE syndrome which has been reported with multiple NSAIDs including diclofenac, naproxen, meloxicam, fenbufen, nimesulide and diflunisal). 22932657
Smetana M, Picard K, Boehm KM. An acute ibuprofen overdose masking a severe Staphylococcus aureus meningitis: a case report. Case Rep Emerg Med. 2013;2013:603251. (53 year old man with severe back pain self-medicated with 70 ibuprofen tablets and presented with weakness and nausea, initial blood tests showing normal ALT and AST, but he subsequently developed refractory hypotension and cardio-respiratory arrest but recovered after 38-day hospitalization). 23840977
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. PMID: (Analysis of cases of idiopathic acute liver failure undergoing liver transplantation in 52 centers in Europe between 2005 and 2007, found 40 had been exposed to an NSAID [14 to ibuprofen] within the previous 30 days with estimated event rates of 2.3 per million treatment-years for ibuprofen). 23325533
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Adsociation Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of 42,389 spontaneous serious adverse event reports to the French Pharmacovigilance database on 8 NSAIDs between 2002 and 2006; liver adverse events were most frequent with nimesulide [0.15 per million daily doses] compared to diclofenac [0.09], ketoprofen [0.09] piroxicam [0.06], naproxen [0.04], meloxicam [0.03], and tenoxicam [0.03]; ibuprofen not discussed). 21929527
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd], but none for ibuprofen or other NSAIDs). 23419359
Nayudu SK, Kavuturu S, Niazi M, Daniel M, Dev A, Kumbum K. A rare coexistence: drug induced hepatitis and meningitis in association with Ibuprofen. J Clin Med Res 2013; 5: 243-6. (38 year old woman was found to have abnormal liver tests a week after starting over-the-counter ibuprofen for knee pain [bilirubin 0.4 mg/dL, ALT 249 U/L, Alk P 31 U/L], resolving within 2 weeks of stopping). 23671551
Pliskow S. Severe gynecologic sequelae of Stevens-Johnson syndrome and toxic epidermal necrolysis caused by ibuprofen: a case report. J Reprod Med 2013; 58 (7-8): 354-6. (3 year old girl developed toxic epidermal necrolysis after receiving ibuprofen for an upper respiratory infection and suffered complications of respiratory failure, blindness in one eye, recurrent sinusitis and pneumonia, nerve damage and severe gynecological sequelae including vaginal obliteration due to scarring discovered when she was 13; no mention of hepatic involvement). 23947089
Balint B, Stepic N, Todorovic M, Zolotarevski L, Ostojic G, Vucetic D, Pavlovic M, Novakovic M. Ibuprofen-induced extensive toxic epidermal necrolysis - a multidisciplinary therapeutic approach in a single case. Blood Transfus 2014; 12: 438-9. (21 year old woman developed toxic epidermal necrolysis after taking ibuprofen for headache [ALT 145 U/L, bilirubin and Alk P not given], with recovery after a month of treatment with corticosteroids, intravenous immunoglobulin, antibiotics, leukopheresis and plasma exchange). 25074525
Kim HY, Yang HK, Kim SH, Park JH. Ibuprofen associated acute vanishing bile duct syndrome and toxic epidermal necrolysis in an infant. Yonsei Med J 2014; 55: 834-7. (7 month old girl developed rash 2 days after starting ibuprofen for fever with progression to toxic epidermal necrolysis and cholestatic liver injury [bilirubin 0.5 rising to 9.5 mg/dL, ALT 523 U/L, Alk P 500 U/L], with a prolonged course and biopsy showing paucity of bile ducts but ultimate full recovery within 3 months). 24719156
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDS [n=62, 32%], but specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]; ibuprofen was not listed]). 24552865
Mengual-Moreno E, Lizarzábal-García M, Ruiz-Soler M, Silva-Suarez N, Andrade-Bellido R, Lucena-González M, Bessone F, et al. Informes de casos de lesión hepática inducida por fármacos en un hospital de referencia del estado Zulia, Venezuela [Case reports of drug-induced liver injury in a reference hospital of Zulia state, Venezuela]. Invest Clin 2015; 56: 3-12. Spanish. PMID: 25920181 (Among 13 cases of drug induced liver injury seen at a single Venezuelan medical center during 2012-13, the most commonly implicated agents were ibuprofen [n=3: 23%], acetaminophen [n=3], isoniazid [n=2] and Herbalife products [n=2]).
Roales-Gómez V, Molero AI, Pérez-Amarilla I, Casabona-Francés S, Rey-Díaz-Rubio E, Catalán M, Vanaclocha F, et al. DRESS syndrome secondary to ibuprofen as a cause of hyperacute liver failure. Rev Esp Enferm Dig. 2014;106:482-6. (22 year old Spanish man developed rash and fever shortly after starting ibuprofen [1,200 mg daily] which was stopped but then restarted and he presented with metabolic acidosis, hypotension, eosinophilia, and liver tests abnormalities [bilirubin 3.0 mg/dL, ALT 174 U/L, AST 58 U/L] which worsened over the next 48 hours [bilirubin 2.9 mg/dL, ALT 2154 U/L, AST 1168 U/L] and he underwent successful emergency liver transplantation). 25490169
Watanabe T, Abe M, Tada F, Aritomo K, Ochi H, Koizumi Y, Tokumoto Y, et al. Drug-induced liver injury with serious multiform exudative erythema following the use of an over-the-counter medication containing ibuprofen. Intern Med 2015; 54: 395-9. (36 year old Japanese woman developed severe rash, mild eosinophilia [7%] and liver dysfunction [DRESS] 5 days after a 25 day course of an over-the-counter product that contained ibuprofen [bilirubin 15.3 mg/dL, ALT 1800 U/L, Alk P 332 U/L, INR 1.7], resolving with corticosteroid therapy within 4 weeks of onset). 25748955
Jessurun N, van Puijenbroek E. Relationship between structural alerts in NSAIDs and idiosyncratic hepatotoxicity: an analysis of spontaneous report data from the WHO database. Drug Saf 2015; 38: 511-5. (Analysis of reports of liver injury in WHO database for 5 NSAIDs in relation to several structural "alerts" found an association with higher rates of hepatotoxicity comparing diclofenac, lumiracoxib and bromfenac [that have structural alerts] with naproxen and ibuprofen [that do not]). 25787329
Dharamsi FM, Michener MD, Dharamsi JW. Bullous fixed drug eruption masquerading as recurrent Stevens Johnson syndrome. J Emerg Med 2015; 48: 551-4. (Two patients with suspected recurrent Stevens Johnson syndrome were diagnosed with recurrent fixed drug reactions, one to ibuprofen and one to sulfamethoxazole-trimethoprim; no mention of ALT elevations or jaundice in either case). 25433836
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs, including 1 to ibuprofen [Schmeltzer 2016]). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, including 2 due to ibuprofen, both in patients with underlying chronic liver disease [cirrhosis from chronic hepatitis C and alcoholism and chronic autoimmune hepatitis]). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al.; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59], and risk was higher in those taking higher doses). 26991794
Basturk A, Artan R, Yılmaz A, Gelen MT, Duman O. Acute vanishing bile duct syndrome after the use of ibuprofen. Arab J Gastroenterol 2016; 17: 137-9. (7 year old boy developed rash 3 days after starting ibuprofen syrup which progressed to toxic epidermal necrolysis accompanied by liver injury [bilirubin 5.2 rising to 10.3 mg/dL, ALT 319 U/L, Alk P 1018 U/L], biopsy showing bile duct loss and jaundice lasting for several months, but ultimately resolving completely). 27658326
Angadi SS, Karn A. Ibuprofen induced Stevens-Johnson syndrome - toxic epidermal necrolysis in Nepal. Asia Pac Allergy 2016; 6: 70-3. (22 year old Nepalise man developed rash 2 days after starting ibuprofen that progressed rapidly to toxic epidermal necrolysis [ALT 150 U/L, bilirubin and Alk P not given, INR 1.37], with 5 week hospitalization and intensive care, but ultimate full recovery). 26844223
Suwarsa O, Yuwita W, Dharmadji HP, Sutedja E. Stevens-Johnson syndrome and toxic epidermal necrolysis in Dr. Hasan Sadikin General Hospital Bandung, Indonesia from 2009-2013. Asia Pac Allergy 2016; 6: 43-7. (Between 2009 and 2014, 39 cases of Stevens Johnson syndrome, 11 of toxic epidermal necrolysis and 7 of overlap of the two were seen at a single referral hospital in Indonesia with suspected causes being acetaminophen [17%], carbamazepine [7%], amoxicillin [6%] and ibuprofen [4.5%], of whom 7 died [12%] of sepsis or respiratory failure; 19 [33%] had liver involvement, but few details given). 26844219
Belver MT, Michavila A, Bobolea I, Feito M, Bellón T, Quirce S. Severe delayed skin reactions related to drugs in the paediatric age group: A review of the subject by way of three cases (Stevens-Johnson syndrome, toxic epidermal necrolysis and DRESS). Allergol Immunopathol (Madr) 2016; 44: 83-95. PMID: (Review of severe cutaneous adverse reactions to drugs in children and 3 case reports, 2 attributed to amoxicillin-clavulanate and ibuprofen and one to phenytoin, none with liver involvement). 26089185
Benmoussa J, Chevenon M, Nandi M, Forlenza TJ, Nfonoyim J. Ibuprofen-induced thrombotic thrombocytopenic purpura. Am J Emerg Med. 2016;34:942.e5-7. (37 year old African-American man was found unresponsive after a 12 g ibuprofen overdose with blood tests showing thrombocytopenia [29,000/μL], anemia [hematocrit 19%] and abnormal liver tests [bilirubin 7.1 mg/dL, ALT 30 U/L, AST 186 U/L, Alk P 77 U/L, LDH 2308 U/L], but full recovery after medical support). 26643158
Sheridan DC, Hendrickson RG, Lin AL, Fu R, Horowitz BZ. Adolescent suicidal ingestion: national trends over a decade. J Adolesc Health. 2017;60:191-195. (Analysis of the U.S. National Poison Data System for intentional suicide by adolescents between 2004 to 2013 found the most common ingested substances to be acetaminophen [11%], ibuprofen [9%], antidepressants [8%], atypical antipsychotics [6%] and histamines [5%], with the greatest number of deaths attributed to the antipsychotics and antidepressants). 27889404
Moore N, Scheiman JM. Gastrointestinal safety and tolerability of oral non-aspirin over-the-counter analgesics. Postgrad Med. 2018;130:188-199. (Review of the gastrointestinal and hepatic safety of over-the-counter analgesics including ibuprofen does not mention serious hepatic effects). 29417856
Zoubek ME, González-Jimenez A, Medina-Cáliz I, Robles-Díaz M, Hernandez N, Romero-Gómez M, Bessone F, et al. High prevalence of ibuprofen drug-induced Liver injury in Spanish and Latin-American registries. Clin Gastroenterol Hepatol 2018; 16: 292-4. (Analysis of a Spanish and Latin-American registries identified 73 cases of NSAID induced liver injury, the most common agents being nimesulide [38%], diclofenac [34%] and ibuprofen [17%], the 26 ibuprofen cases being 50% female, ages 18 to 77 years, 65% with jaundice, 58% hospitalized, 24% with eosinophilia, 58% hepatocellular and 3 [12%] with fatal outcome; nevertheless, ibuprofen related liver injury did not have a single or distinctive clinical signature). 28782674
Teschke R. Top-ranking drugs out of 3312 drug-induced liver injury cases evaluated by the Roussel Uclaf Causality Assessment Method. Expert Opin Drug Metab Toxicol. 2018;14:1169-1187. (In a review of 3312 published cases of drug-induced liver injury using RUCAM to define causality, ibuprofen ranked 8^th^ in frequency with 37 cases). 30354694
Shahnazarian V, Ramai D, Reddy M. A rare case of ibuprofen-induced acute liver injury. Cureus. 2018;10:e3225. (29 year old woman developed lethargy and confusion shortly after a suicidal overdose of ibuprofen [60 gm] which resolved by day 3 when liver test abnormalities were found [initial bilirubin 1.8 rising to 6.5 mg/dL, ALT 283 rising to 1873 U/L, Alk P 85 rising to 135 U/L, INR 1.9] with peak values on days 7 to 8 which then resolved). 30410832
Xie W, Wang Q, Gao Y, Pan CQ. Vanishing bile duct syndrome with hyperlipidemia after ibuprofen therapy in an adult patient: a case report. BMC Gastroenterol. 2018;18:142. (40 year old woman taking 600 mg of ibuprofen for 2 to 3 days monthly for 6 months for menalgia developed jaundice immediately after the 6^th^ short course [bilirubin 6.0 mg/dL, ALT 207 U/L, Alk P 1598 U/L], with persistence of jaundice and marked elevations in Alk P for 10 months and liver biopsies showing vanishing bile duct syndrome). 30268094
Gulmez SE, Unal US, Lassalle R, Chartier A, Grolleau A, Moore N. Risk of hospital admission for liver injury in users of NSAIDs and nonoverdose paracetamol: Preliminary results from the EPIHAM study. Pharmacoepidemiol Drug Saf. 2018;27:1174-1181. (In a case-population controlled study of a French hospitalization claims database, 63 cases of acute liver injury were identified, 13 of which had been exposed to an NSAID including 4 to ibuprofen). 30112779
Hawton K, Ferrey A, Casey D, Wells C, Fuller A, Bankhead C, Clements C, et al. Relative toxicity of analgesics commonly used for intentional self-poisoning: A study of case fatality based on fatal and non-fatal overdoses. J Affect Disord. 2019;246:814-819. (Analysis of national databases on suicide deaths in the UK between 2005 and 2012 calculated the self-poison rate and overall death rate per 100,000 population as 151 and 0.17 for acetaminophen compared to 55 and .004 for ibuprofen, thus having a high poison rate but low morality rate). 30634113
Rosenthal MG, Labato MA. Use of therapeutic plasma exchange to treat nonsteroidal anti-inflammatory drug overdose in dogs. J Vet Intern Med. 2019;33:596-602. (Among 6 dogs with ibuprofen overdose, the 2 with the highest ingestion developed renal dysfunction which was chronic in one; no mention of abnormal liver tests or hepatic injury). 30698297
Zoubek ME, Lucena MI, Andrade RJ, Stephens C. Systematic review: ibuprofen-induced liver injury. Aliment Pharmacol Ther. 2020;51:603-611. (Review of the published literature identified 22 cases of “idiosyncratic” liver injury attributed to ibuprofen, 55% female and mean age 31 years, most cases being hepatocellular, with 6 cases of vanishing bile duct syndrome and 5 of acute liver failure). 31984540
Alhaddad O, Elsabaawy M, Abdelsameea E, Abdallah A, Shabaan A, Ehsan N, Elrefaey A, et al. Presentations, causes and outcomes of drug-induced liver injury in Egypt. Sci Rep. 2020;10:5124. (Among 75 patients hospitalized for drug-induced liver injury at an Egyptian referral center in 2015 and 2016, the most frequent causes were diclofenac [n=31, 43%], amoxicillin/clavulanate [14, 19%], halothane [8, 11%], and ibuprofen [4, 5%] among whom the mean latency to onset was 8 days). 32198411
Gui MZ, Ni M, Yin XD, Zhang T, Li ZL. Ibuprofen induced Stevens-Johnson syndrome and liver injury in children: a case report. Transl Pediatr. 2021;10:1737-1742. (9 year old girl developed somnolence, anorexia, abdominal pain, and rash shortly after starting ibuprofen for fever [bilirubin 4.0 rising to 10.9 mg/dL, ALT 1416 U/L, GGT 669 U/L] with progressive spread of the rash and sloughing of skin suggestive of Stevens Johnson syndrome, with apparent resolution within the next 2 months). 34295789
Pollack BE, Barbaro RP, Selewski DT, Carlton EF. Lactic acidosis and multisystem organ failure following ibuprofen overdose requiring haemodialysis. BMJ Case Rep. 2022;15:e244281. (17 year old boy was found somnolent with mild metabolic acidosis but normal kidney and liver tests within a few hours of an overdose of ibuprofen of unknown amount but became less responsive at 24 hours with worsening hypotension and lactic acidosis requiring hemodialysis which led to resolution of the acidosis and hypotension within 10 hours, and he ultimately recovered completely). 35131772
Farah R, Rege SV, Cole RJ, Holstege CP. Suspected suicide attempts by self-poisoning among persons aged 10-19 years during the COVID-19 pandemic – United States, 2020-2022. MMWR Morb Mortal Wkly Rep. 2023;72:426-430. (Rates of ibuprofen self-poisoning among children, ages 10-19 years, increased during the COVID pandemic years compared to 2019 by 3.1% in 2020, 35% in 2021, and 16% in 2022, numbers of reports and increases being second only to acetaminophen [21%, 71% and 58%]). 37079475
Medford S, Jalal Eldin A, Brgdar A, Obwolo L, Ojo AS, Mere C, Ali A. Beyond the norm: a case of multiorgan injury triggered by ibuprofen. Cureus. 2023;15:e46461. (71 year old with chronic pulmonary disease, heart failure, multiple strokes, COVID-19 pneumonia, interstitial nephritis, and cocaine use developed autoimmune hemolytic anemia, thrombocytopenia, and acute liver failure [bilirubin 6.8 mg/dL, ALT above 5,000 U/L, AST 8,711 U/L, Alk P not given, INR 2.6] which resolved within days of stopping high doses of over-the-counter ibuprofen which he had taken for several weeks for abdominal pain). 37927669
Wong K, Cha B, Wu S. Case of ibuprofen-induced liver injury. Ann Intern Med Clin Cases. 2023;2:e220880. Not in PubMed. (64 year old man developed abdominal pain and was found to have anormal liver tests 2 weeks after starting 2.4 g of ibuprofen daily [bilirubin 0.8 mg/dL, ALT 763 U/L, AST 761 U/L, Alk P 198 U/L, INR 1.0], which resolved upon stopping and all values were normal in follow up).
Liu Y, Liu MW. An unusual presentation of liver failure caused by ibuprofen-sustained release capsules: A case report. Medicine (Baltimore). 2024;103:e36997. (65 year old man developed dark urine 1 day after taking a single capsule of “long-acting ibuprofen” [bilirubin 4.6 mg/dL, ALT 1793 U/L, Alk P not given, INR 1.8], with marked improvement within 2 weeks of stopping). 38277537
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-Update with genetic correlations. Liver Int. 2024;44:1409-1421. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, only 5 were attributed to ibuprofen [ranking 3^rd^ among NSAIDs behind diclofenac and celecoxib] including 3 women, average age 55 years, median latency of 31 days, initial ALT 728 U/L, AST 497 U/L, Alk P 123 U/L, R ratio 20.5, bilirubin 2.3 mg/dL, none with ANA or SMA, none fatal, and all resolving without evidence of chronic injury). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at a rate of 1 per 11,000 patients treated with ibuprofen). 38913369
Weigel B, Adams A, Wahrenbrock T, Wahl M. Adolescent acetaminophen and ibuprofen self-poisoning, 2017-2022. Pediatr Emerg Care. 2024;40:776-780. (Analysis of data from the U.S. National Poison Data System between 2017 and 2022 found 41,674 ibuprofen compared to 50,902 acetaminophen self-poisoning reports in teenagers, rates peaking in 2021 with 29 ibuprofen vs 40 acetaminophen cases per 100,00 persons, ibuprofen more frequently leading to central nervous system depression and metabolic acidosis, and acetaminophen to elevations in ALT levels and death (odds ratio 14 compared to ibuprofen]). 39180188
Ershad M, Ameer MA, Chen RJ, Vearrier D. Ibuprofen toxicity. 2024 Apr 30. In: StatPearls [Internet]. Treasure Island (FL): StatPearls Publishing; 2025 Jan (Review of ibuprofen toxicity states that “ibuprofen is commonly associated with drug-induced liver injury, both in overdose and in therapeutic use.”).
Alvarez-Martin LR, Esquivel-Pacheco LA, Hinostroza-Pezo AV, Arroyo-Garcia KJ, Moreno-Huesca MD, Feria-Avendano AZ, Galvan-Castro CA. Acute liver failure triggered by idiosyncratic drug-induced liver injury associated with ibuprofen consumption. case report. Ann Hepatol 2025;30:101791. Not in PubMed. (43 year old woman taking ibuprofen [1.2 g daily] developed abdominal pain and jaundice but continued the agent for another 4 weeks [bilirubin 7.8 mg/dL, ALT 1183 U/L, Alk P 311 U/L, INR prolonged] with progression to hepatic failure and death).
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 483 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 11 [2%] to ibuprofen [mean age 44, 55% women, 91% hepatocellular, none fatal]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Ibuprofen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=ibuprofen/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ibuprofen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ibuprofen)